# Benign Prostatic Hypertrophy Agents

## OVERVIEW

Drugs used for the symptomatic treatment of benign prostatic hypertrophy (BPH) include the alpha-1 adrenergic receptor antagonists (alpha blockers) and the 5-alpha reductase inhibitors. The alpha-1 adrenergic blockers act by relaxation of the smooth muscle in the bladder neck and prostate, which results in improvement in urine flow in men with partial obstruction due to an enlarged prostate. The 5-alpha reductase inhibitors act by inhibition of the conversion of testosterone to dihydrotestosterone, which is an important prostatic growth factor. Decrease in dihydrotesterone levels lead to a gradual shrinkage of the prostate, which can improve urine flow in men. Thus, the two classes of agents have different mechanisms of action and targets and have little cross reactivity in side effects.

In general, these agents are very rare causes of liver injury.

References to safety and hepatotoxicity are given in the two Overview sections and the specific agents are discussed individually:

- Alpha-1 Adrenergic Receptor Antagonists
  - Alfuzosin, Silodosin, Tamsulosin, Doxazosin, Terazosin
- 5-Alpha Reductase Inhibitors
  - Dutasteride, Finasteride